# Thalidomide

## OVERVIEW

### Introduction

Thalidomide and its analogues lenalidomide and pomalidomide are immunomodulatory and antineoplastic agents that are used in the therapy of multiple myeloma. These three agents are associated with a low rate of serum aminotransferase elevations during therapy and have been implicated in causing rare instances of clinically apparent liver injury which can be severe.

### Background

Thalidomide (tha lid' oh mide) is a glutamic acid derivative that was introduced in Europe as a sedative in the late 1950s and subsequently withdrawn in 1961 when it was shown to be teratogenic, causing severe infant limb defects (phocomelia) when given to pregnant women. Several decades later, thalidomide was found to have potent activity in erythema nodosum leprosum, and subsequent studies found it beneficial in several autoimmune conditions and cancers. Thalidomide has immunomodulatory, antiinflammatory, antiangiogenic and anticancer properties that underlie its effects in inflammatory and malignant diseases. Thalidomide was approved for therapy of erythema nodosum leprosum (ENL) in the United States in 1998 and was subsequently approved for use in multiple myeloma (in combination with dexamethasone) in 2006. Lenalidomide (len" a lid' oh mide) and pomalidomide ae thalidomide derivatives that were found to be more potent as antineoplastic agents, and were subsequently approved for use in selected myelodysplastic syndromes and for multiple myeloma (combined with dexamethasone). Thalidomide has also been used on an experimental basis for graft vs host disease, Kaposi sarcoma, AIDS associated wasting syndrome and several forms of autoimmune disease. Thalidomide is available in capsules of 50, 100, 150 and 200 mg under the brand name Thalomid. The recommended dose varies by indication, and its use is restricted because of their proven teratogenicity. Side effects of thalidomide are common and include sedation, dizziness, orthostatic hypotension, neutropenia, thrombocytopenia, peripheral neuropathy, and venous and arterial thromboembolism (for which reason it is usually given with anticoagulation). Rare but potentially severe adverse events include severe cutaneous reactions, seizures, tumor lysis syndrome and hypersensitivity reactions. Thalidomide is a known teratogen and cause of severe birth defects and is available only as a part of a strict Risk Evaluation and Mitigation Strategy (REMS), which requires physician training, patient fully informed consent, strict birth control measures, monitoring and reporting.

### Hepatotoxicity

Serum enzyme elevations occur in 8% to 15% of patients taking thalidomide and are more frequent with higher doses. The enzyme abnormalities are usually mild and self-limited, and only rarely require drug discontinuation. In addition, both thalidomide and its derivatives, lenalidomide and pomalidomide, have been implicated in rare instances of clinically apparent, acute liver injury which can be severe and has led to deaths from acute liver failure. The onset of injury is typically within 1 to 8 weeks of starting therapy. The pattern of serum enzyme elevation at the time of presentation can be either hepatocellular or cholestatic; however, the injury tends to be cholestatic and can be prolonged. Immunoallergic and autoimmune features are not common. Several instances of acute liver injury associated with thalidomide therapy have occurred in patients with other apparent causes of liver disease or with preexisting chronic hepatitis B or C. If performed during the acute injury, liver biopsy shows hepatocellular necrosis and inflammatory cell infiltration, consistent with acute drug induced injury. In some instances there is bile duct injury and loss resulting in progressive cholestatic liver injury suggestive of vanishing bile duct syndrome. Thalidomide and its derivatives have also been implicated in causing an increased risk of graft-vs-host disease after autologous or allogeneic hematopoietic stem cell transplantation (HSCT). There appears to be cross reactivity to this complication among thalidomide and its two derivatives. Therapy usually requires discontinuation of the antineoplastic agent as well as treatment with high doses of corticosteroids and tacrolimus or sirolimus.

Reactivation of hepatitis B has been reported in patients receiving thalidomide, lenalidomide and pomalidomide, but generally only after HSCT. In studies of large numbers of patients treated for multiple myeloma with these agents, the major risk factor for reactivation was HSCT rather than the specific antineoplastic drugs being used. Indeed, lenalidomide therapy was associated with a reduced risk of reactivation in patients with HSCT (although dexamethasone, thalidomide and bortezomib were not), perhaps because of the typical immune enhancement caused by lenalidomide.

Likelihood score: B (well known but rare cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism of thalidomide hepatotoxicity is not clear, but it may be related to its activity in reducing TNF-α production, a potent inflammatory cytokine that activates T cells and promotes inflammation, but is also necessary for normal liver regeneration. Several of the reported cases of hepatotoxicity have occurred in patients with underlying chronic liver disease (hepatitis B, C or nonalcoholic fatty liver), and another possibility is that thalidomide may worsen preexisting hepatic conditions.

### Outcome and Management

The severity of thalidomide induced liver injury ranges from transient, asymptomatic elevations in serum enzymes to acute liver injury with jaundice to severe acute liver failure and death. The liver injury usually starts to resolve within a week of stopping the medication, but prolonged jaundice with bile duct injury and possible vanishing bile duct syndrome have also been reported. Rechallenge should be reserved for cases of mild liver injury in which the agent is considered very necessary and done with caution and careful monitoring. Nevertheless, instances of reinitiation of therapy without subsequent recurrence of liver injury have been reported.

Drug Class: Antineoplastic Agents, Miscellaneous

Other Related Drugs: Lenalidomide, Pomalidomide

## CASE REPORT

### Case 1. Acute hepatitis due to thalidomide.(1)

A 76 year old woman with multiple myeloma developed jaundice 5 weeks after starting thalidomide combined with warfarin and intermittent dexamethasone. She had no previous history of liver disease or risk factors for viral hepatitis. She did not drink alcohol. Her only other medications were metoprolol and furosemide for hypertension and insulin for diabetes. Routine liver tests had been normal in the past. Routine monitoring of serum enzymes demonstrated rises in ALT and AST after 4 weeks of treatment. Thalidomide was continued, and one week later she developed nausea, fatigue, abdominal discomfort and jaundice. On physical examination, she was jaundiced but had no fever, rash or signs of chronic liver disease. Laboratory tests showed bilirubin 5.6 mg/dL, ALT 2206 U/L, and international normalized ratio (INR) of greater than 15. She was admitted to the hospital for management and both thalidomide and the warfarin were stopped. Tests for hepatitis A, B and C were negative as were autoantibodies. Imaging of the liver showed evidence of diffuse fatty liver, but no masses or biliary obstruction. She was treated with fresh frozen plasma to correct the INR and underwent transjugular liver biopsy which was interpreted as compatible with acute drug induced liver injury superimposed upon an underlying nonalcoholic steatohepatitis. After thalidomide was stopped, she began to improve rapidly (Table). She was discharged after a week in the hospital and, when seen three months later, her liver tests were normal.

#### Key Points

Medication: | Thalidomide
Pattern: | Hepatocellular (R value could not be determined)
Severity: | 3+ (jaundice and hospitalization)
Latency: | 4 to 5 weeks
Recovery: | Complete within 30 days
Other medications: | Furosemide, metoprolol, insulin, warfarin, dexamethasone

#### Laboratory Values

Time After Starting | Time After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | | Normal
4 weeks | | 218 | 179
5 weeks | 0 | 2205 | 2376 | 5.6 | INR >15, admission
| 1 day | 2250 | 2425 | | Thalidomide stopped
| 4 days | 1500 | 1050
6 weeks | 12 days | 165 | 86 | 5.5 | INR 1.1: Discharged
4 months | 3 months | Normal | Normal | Normal | Outpatient follow up
Normal Values | | <34 | <35 | <1.2

* Some values estimated from Figure 1.

#### Comment

This woman developed jaundice within 5 weeks of starting an experimental regimen of cancer chemotherapy including thalidomide, warfarin and dexamethasone. Typical of thalidomide hepatotoxicity was the latency to onset (1 to 3 months), the hepatocellular pattern of injury (although no alkaline phosphatase values were provided in this case), the presence of an underlying liver disease, and the rapid improvement with stopping the medication.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Thalidomide – Thalidomid®

Lenalidomide – Revlimid®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Thalidomide)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Thalidomide | 50-35-1 | C13-H10-N2-O4
Lenalidomide | 191732-72-6 | C13-H13-N3-O3
Pomalidomide | 19171-19-8 | C13-H11-N3-O4

## CITED REFERENCES

1 Hanje AJ, Shamp JL, Thomas FB, Meis GM. (2006). Thalidomide-induced severe hepatotoxicity. Pharmacotherapy.

## ANNOTATED BIBLIOGRAPHY

References updated: 30 August 2022

Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999. (Textbook of hepatotoxicity published in 1999; thalidomide is not discussed).
Davern TJ. Hepatotoxicity of immunomodulating agents and the transplant situation. Thalidomide. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, p. 675. (Mentions that thalidomide rarely causes liver injury, but case reports of hepatocellular injury with variable degrees of jaundice have been described, largely in patients with preexisting chronic liver disease).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Thalidomide and lenalidomide. Pathway targeted therapies: monoclonal antibodies, protein kinase inhibitors, and various small molecules. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1225-27. (Textbook of pharmacology and therapeutics).
Hastings RC, Trautman JR, Enna CD, Jacobson RR. (1970). Thalidomide in the treatment of erythema nodosum leprosum. With a note on selected laboratory abnormalities in erythema nodosum leprosum. Clin Pharmacol Ther. (Results of treating 22 patients with leprosy with thalidomide showed excellent results, often allowing for discontinuation of corticosteroids without significant toxicity).
Tseng S, Pak G, Washenik K, Pomeranz MK, Shupack JL. (1996). Rediscovering thalidomide: a review of its mechanism of action, side effects, and potential uses. J Am Acad Dermatol. (Review of history, mechanism of action, side effects and uses of thalidomide; thalidomide has many side effects, but hepatic adverse events were not mentioned).
Singhal S, Mehta J, Desikan R, Ayers D, Roberson P, Eddlemon P, Munshi N, et al. (1999). Antitumor activity of thalidomide in refractory multiple myeloma. N Engl J Med. (Trial of oral thalidomide in 84 patients with advanced myeloma found some response in 78% and remissions in 10%; adverse events were common, but no mention of ALT elevations or liver injury).
Clark TE, Edom N, Larson J, Lindsey LJ. (2001). Thalomid (Thalidomide) capsules: a review of the first 18 months of spontaneous postmarketing adverse event surveillance, including off-label prescribing. Drug Saf. (During first 18 months of postmarketing use of thalidomide in 10,456 patients, 1210 adverse event reports were received, including 4 cases of hepatic failure arising after 1-4 weeks of treatment, although 3 were considered unrelated to therapy).
Fowler R, Imrie K. (2001). Thalidomide-associated hepatitis: a case report. Am J Hematol. (Patient with chronic hepatitis C and advanced plasma cell leukemia developed jaundice and nausea 1 week after starting thalidomide [bilirubin 0.4 initially rising to 9.3 mg/dL, ALT 91 to 829 U/L, Alk P 100 to 120 U/L], resolving rapidly upon stopping; high HCV RNA levels noted).
Grover JK, Uppal G, Raina V. (2002). The adverse effects of thalidomide in relapsed and refractory patients of multiple myeloma. Ann Oncol. (Report of adverse effects of thalidomide in 23 patients with myeloma: constipation 100%, sedation 87%, edema 70%, also common were dry skin and mouth, headache, nausea and rash; minor ALT elevations occurred and 1 patient developed acute hepatitis, but it was attributed to hepatitis C).
Ghobrial IM, Rajkumar SV. (2003). Management of thalidomide toxicity. J Support Oncol. (Discussion of management of toxicities of thalidomide focusing upon sedation, constipation, neuropathy, rash, deep vein thrombosis, neutropenia, bradycardia and seizures; "elevated liver enzymes may occur in some patients").
Seldin DC, Choufani EB, Dember LM, Wiesman JF, Berk JL, Falk RH, O'Hara C, et al. (2003). Tolerability and efficacy of thalidomide for the treatment of patients with light chain-associated (AL) amyloidosis. Clin Lymphoma. (Among 16 patients with amyloidosis given thalidomide to maximum tolerated dose, side effects included fatigue, sedation, constipation, headaches, fluid retention, and changes in thyroid tests and creatinine; no mention of liver abnormalities).
Trojan A, Chasse E, Gay B, Pichert G, Taverna C. (2003). Severe hepatic toxicity due to thalidomide in relapsed multiple myeloma. Ann Oncol. (62 year old woman with multiple myeloma developed acute liver failure after 7 months of thalidomide therapy [bilirubin not given, ALT ~2000 U/L, LDH ~6000 U/L], enzymes falling to normal in 1 week; overall, suggestive of ischemic hepatitis rather than hepatotoxicity).
Teo SK. (2005). Properties of thalidomide and its analogues: implications for anticancer therapy. AAPS J. (Review of the properties and experimental uses of thalidomide as an inhibitor of TNF-α and other cytokines in multiple myeloma and several solid tumors).
List A, Kurtin S, Roe DJ, Buresh A, Mahadevan D, Fuchs D, Rimsza L, et al. (2005). Efficacy of lenalidomide in myelodysplastic syndromes. N Engl J Med. (Open label study of lenalidomide in 43 patients with myelodysplasia and anemia due to myelodysplastic syndrome reported neutropenia in 65% and thrombocytopenia in 74% of patients, and need for dose modification in 25%, but no mention of liver abnormalities).
Caseiro MM. (2006). Treatment of chronic hepatitis C in non-responsive patients with pegylated interferon associated with ribavirin and thalidomide: report of six cases of total remission. Rev Inst Med Trop Sao Paulo. (Report of improvement in virological and biochemical responses to peginterferon and ribavirin therapy of chronic hepatitis C by addition of thalidomide [100 mg daily]; no mention of side effects).
Hanje AJ, Shamp JL, Thomas FB, Meis GM. (2006). Thalidomide-induced severe hepatotoxicity. Pharmacotherapy. (Elderly woman with myeloma developed jaundice and marked ALT elevations after 6 weeks of thalidomide therapy [ALT 2205 U/L; bilirubin 5.6 mg/dL], resolving within 3 months of stopping: Case 1).
Hamadani M, Benson DM, Copelan EA. (2007). Thalidomide-induced fulminant hepatic failure. Mayo Clin Proc. (64 year old woman with multiple myeloma and HBsAg in serum developed acute liver failure 12 days after starting thalidomide [bilirubin 16.7 mg/dL, ALT 410 U/L, Alk P 101 U/L, no change in HBV DNA], some improvement on stopping drug, but had worsening coagulopathy and renal failure and died 14 days later).
Melchert M, List A. (2007). The thalidomide saga. Int J Biochem Cell Biol. (Review of history of thalidomide and current understanding of its actions as an anticytokine; no mention of side effects).
Hussain S, Browne R, Chen J, Parekh S. (2007). Lenalidomide-induced severe hepatotoxicity. Blood. (57 year old man with multiple myeloma developed jaundice 1 week after starting lenalidomide, a derivative of thalidomide [bilirubin 7.2 mg/dL, ALT 90 U/L, Alk P 210 U/L], resolving within 3 weeks).
Weber DM, Chen C, Niesvizky R, Wang M, Belch A, Stadtmauer EA, Siegel D, et al. (2007). Multiple Myeloma (009) Study Investigators. Lenalidomide plus dexamethasone for relapsed multiple myeloma in North America. N Engl J Med. (Controlled trial of lenalidomide in 353 patients with relapsed multiple myeloma showed improvement in response rates and survival time; side effects were common, but no mention of liver abnormalities).
Dimopoulos M, Spencer A, Attal M, Prince HM, Harousseau JL, Dmoszynska A, San Miguel J, et al. (2007). Multiple Myeloma (010) Study Investigators. Lenalidomide plus dexamethasone for relapsed or refractory multiple myeloma. N Engl J Med. (Controlled trial of lenalidomide in 351 patients with refractory multiple myeloma showed improvement in response rates and survival time; side effects of neutropenia, muscle cramps, constipation, nausea and dizziness were common, but liver abnormalities were not mentioned).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, none were attributed to thalidomide or lenalidomide).
Dabak V, Kuriakose P. (2009). Thalidomide-induced severe hepatotoxicity. Cancer Chemother Pharmacol. (2 women with multiple myeloma; 79 year old developed jaundice 7 weeks after starting thalidomide [bilirubin 27.9 mg/dL, ALT 392 U/L, Alk P 1172 U/L], with persistent jaundice, bile duct loss on liver biopsy and death 4 months later; 57 year old developed raised enzymes one month after starting thalidomide [bilirubin not given, ALT 398 U/L, Alk P 175 U/L], resolving within 2 weeks of stopping).
Levesque E, Bradette M. (2009). Hepatotoxicity as a rare but serious side effect of thalidomide. Ann Hematol. (36 year old woman with multiple myeloma developed liver test abnormalities 5 weeks after starting thalidomide [bilirubin normal, peak ALT ~1300 U/L], resolving within 20 days of stopping).
Jain P. (2009). Lenalidomide-induced acute liver failure. Blood Transfus. (93 year old man with myelodysplastic syndrome and HBsAg in serum developed jaundice 10 days after starting lenalidomide [bilirubin 9.2 mg/dL, ALT 2670 U/L, Alk P 342 U/L, IgM anti-HBc positive, but HBV DNA negative], resolving over following 4 weeks and patient later tolerated restarting lenalidomide in combination with adefovir).
Castaneda CP, Brandenburg NA, Bwire R, Burton GH, Zeldis JB. (2009). Erythema multiforme/Stevens-Johnson syndrome/toxic epidermal necrolysis in lenalidomide-treated patients. J Clin Oncol. (After approximately 57,000 patients had received lenalidomide, the sponsor received 12 reports of Stevens-Johnson Syndrome, 3 of erythema multiforme and 1 of toxic epidermal necrolysis, arising 3-112 days after starting; often sparse data were available and there was no mention of liver injury or jaundice).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, but none were attributed to thalidomide).
Zanella MC, Rubbia-Brandt L, Giostra E, Chalandon Y, Hadengue A, Spahr L. (2011). A Case of drug-induced hepatitis due to lenalidomide. Case Rep Gastroenterol. (50 year old man developed severe skin rash 3 months after starting lenalidomide that resolved upon stopping, but developed serum enzyme elevations one week after restarting lenalidomide 2 years later [bilirubin normal, ALT 509 U/L, Alk P 198 U/L], resolving upon stopping).
Vilas-Boas F, Gonçalves R, Sobrinho Simões M, Lopes J, Macedo G. (2012). Thalidomide-induced acute cholestatic hepatitis: Case report and review of the literature. Gastroenterol Hepatol. (77 year old man with multiple myeloma developed jaundice 4 weeks after starting chemotherapy with melphalan, prednisone and thalidomide [bilirubin 11.4 mg/dL, ALT 333 U/L, Alk P 4 times ULN], worsening for a week after stopping thalidomide and then improving; patient later tolerated melphalan, but died of pneumonia shortly thereafter).
Shao YY, Lin ZZ, Hsu C, Lee KD, Hsiao CH, Lu YS, Huang CC, et al. (2012). Efficacy, safety, and potential biomarkers of thalidomide plus metronomic chemotherapy for advanced hepatocellular carcinoma. Oncology. (Pilot study of thalidomide combined with tegafur for advanced hepatocellular carcinoma in 43 patients; ALT/AST levels rose above 5 times ULN in 2 patients [5%], but no details given).
Rance E, Tanner JE, Alfieri C. (2012). Inhibition of IκB kinase by thalidomide increases hepatitis C virus RNA replication. J Viral Hepat. (In cell culture, thalidomide lowered IL8 and NF kappa B and markedly increased HCV replication [17 fold], an effect reversed by increasing NF kappa B signaling).
Garrido Serrano A, León R, Sayago M, Márquez JL. (2012). Thalidomide treatment in cirrhotic patients with severe anemia secondary to vascular malformations. Dig Dis Sci. (Pilot study of thalidomide in 19 patients with cirrhosis and recurrent gastrointestinal bleeding; thalidomide therapy appeared to decrease bleeding episodes, but 8 subjects [42%] developed hepatic encephalopathy, 2 discontinued drug because of side effects, and 2 died).
Nojkov B, Signori C, Konda A, Fontana RJ. (2012). Lenalidomide-associated hepatotoxicity--a case report and literature review. Anticancer Res. (67 year old man with multiple myeloma developed fatigue within 1 week of starting a 2nd 3 week course of lenalidomide [bilirubin 4.4 mg/dL, ALT 139 U/L, Alk P 190 U/L], with rapid resolution upon stopping [within 8 days]).
Veluswamy RR, Ward SC, Yum K, Abramovitz RB, Isola LM, Jagannath S, Parekh S. (2014). Adverse drug reaction: pomalidomide-induced liver injury. Lancet. (50 year old man with multiple myeloma on lenalidomide and dexamethasone after HCT developed ALT elevations [433 U/L], which resolved on stopping but recurred and worsened when later treated after a second HCT with pomalidomide and dexamethasone [bilirubin 13 mg/dL, ALT 3981 U/L, Alk P 259 U/L], resolving after stopping both drugs, but ultimately requiring corticosteroid therapy).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to thalidomide or its derivatives).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 1 case was attributed to thalidomide).
Mahale P, Thomas SK, Kyvernitakis A, Torres HA. (2015). Management of multiple myeloma complicated by hHepatitis C virus reactivation: the role of new antiviral therapy. Open Forum Infect Dis. (74 year old woman with multiple myeloma and chronic hepatitis C had worsening of serum ALT and increase in HCV RNA levels when treated with thalidomide and dexamethasone, which prevented continued therapy until hepatitis C was successfully treated with sofosbuvir and ribavirin).
Safran H, Charpentier KP, Kaubisch A, Mantripragada K, Dubel G, Perez K, Faricy-Anderson K, et al. (2015). Lenalidomide for second-line treatment of advanced hepatocellular cancer: a Brown University oncology group phase II study. Am J Clin Oncol. (Among 40 patients with hepatocellular carcinoma with an inadequate response to sorafenib treated with lenalidomide [25 mg daily for 21 days in 28 day cycles], 6 [15%] had a partial response and toxicities were largely hematologic and rash; 5 patients had ALT elevations above 3 times ULN).
Kootte RS, Faber LM. (2017). Hepatitis E during lenalidomide treatment for multiple myeloma in complete remission. Neth J Med. (69 year old woman with multiple myeloma on lenalidomide after HCT was found to have elevations in liver tests [bilirubin 0.5 mg/dL, ALT 328 U/L, Alk P 241 U/L] accompanied by IgM anti-HEV and HEV RNA [suggesting chronic infection sustained by immunosuppression], viremia and ALT elevations resolving with stopping lenalidomide and not returning when it was restarted).
Bonkovsky HL, Kleiner DE, Gu J, Odin JA, Russo MW, Navarro VM, Fontana RJ, et al., U.S. Drug Induced Liver Injury Network Investigators. (2017). Clinical presentations and outcomes of bile duct loss caused by drugs and herbal and dietary supplements. Hepatology. (Among 363 patients with drug induced liver injury who underwent liver biopsy, 26 [7%] had bile duct loss, including 1 case attributed to lenalidomide and 1 to thalidomide both marked by severe, and relentlessly progressive cholestatic liver injury resulting in death from liver failure within 3 months of onset).
Tsukune Y, Sasaki M, Odajima T, Sunami K, Takei T, Moriuchi Y, Iino M, et al. (2017). Incidence and risk factors of hepatitis B virus reactivation in patients with multiple myeloma in an era with novel agents: a nationwide retrospective study in Japan. Blood Cancer J. (Japanese nationwide analysis of 5078 patients with multiple myeloma identified 760 with resolved hepatitis B [anti-HBc without HBsAg in serum] of whom 7.6% developed reactivation [7.9% at 2 and 14.1% at 5 years], multivariate analysis demonstrating higher rates in those undergoing autologous hematopoietic stem cell transplant [21%:odds ratio=11.6] and lower rates in those receiving lenalidomide [5.2%:odds ratio=0.5], but not thalidomide, bortezomib or dexamethasone).

## OTHER REFERENCE LINKS

1 Recent References on Thalidomide: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Thalidomide/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Thalidomide: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Thalidomide)